# Dactinomycin

## OVERVIEW

### Introduction

Dactinomycin is an intravenously administered, antineoplastic antibiotic that is used in the treatment of solid tumors in children and choriocarcinoma in adult women. In high doses, dactinomycin can cause severe liver injury including sinusoidal obstruction syndrome.

### Background

Dactinomycin (dak” tin oh mye’ sin) is one of the actinomycins, anticancer antibiotics that were discovered by Selman Waksman and colleagues in the 1940s using fermentation exacts from bacteria (Streptomyces). The actinomycins are chromopeptides which bind to double-helical DNA and interrupt RNA transcription, causing cell arrest and inhibition of cell division. Actinomycin D, later named dactinomycin, was isolated from Streptococcus parvullus and was identified as a promising antineoplastic agent. Subsequently, dactinomycin was shown to have antitumor effect against a broad array of solid tumors. Dactinomycin was formally approved for use in the United States in 1964 and continues to be a valuable agent in the therapy of solid tumors of childhood (Wilms tumor, rhabdomyosarcoma) and in choriocarcinoma in adult women. Dactinomycin is available as a solution or lyophilized powder for injection in vials of varying concentrations under the commercial name Cosmegen and must be given by the intravenous route, avoiding tissue extravasation. The dose is based upon indication and body weight; a typical regimen is 10 to 15 mcg/kg daily for 5 days, with repeat courses every 2 to 4 weeks based upon tolerance and antitumor effects. Dactinomycin can also be given as a component of regional perfusion regimens for solid malignancies. Side effects of dactinomycin include bone marrow suppression, anorexia, nausea, diarrhea, glossitis, proctitis, oral ulcers, alopecia, erythema and skin rash.

### Hepatotoxicity

Chemotherapy with dactinomycin in combination with other agents is associated with serum enzyme elevations in a high, but variable proportion of patients depending upon the dose, other agents used as well as the frequency of monitoring and criteria used to define elevations. The ALT elevations are usually asymptomatic and transient and may resolve without dose modification. In many instances, it is difficult to attribute the liver test abnormalities to dactinomycin, because of the exposure to other potentially hepatotoxic agents.

Dactinomycin can also cause a distinctive form of clinically apparent liver injury referred to as hepatopathy-thrombocytopenia syndrome (HTS) that can be severe and even fatal. This syndrome appears to be due to sinusoidal obstruction, but there may also be an element of direct hepatic and bone marrow injury. In large studies, between 1% and 5% of children with cancer treated with regimens including dactinomycin developed acute hepatic injury and thrombocytopenia suggestive of HTS. The syndrome is more common in younger children and with higher doses of dactinomycin. The time to onset is typically within 3 to 6 weeks after the initial dose, often arising 5 to 10 days after the 2nd or 3rd course of cyclic chemotherapy with dactinomycin. The onset of symptoms is sudden, and children characteristically present with right upper quadrant pain or tenderness, hepatomegaly, liver test abnormalities and signs of excessive bleeding such as epistaxis or bruising. Serum aminotransferase levels are markedly elevated (10 to 100 times ULN) early in the course, but fall rapidly and can be normal within 7 to 14 days. The platelet count is generally less than 25,000/μL and also resolves rapidly. Serum alkaline phosphatase is typically normal and bilirubin levels are minimally elevated, except if the course is progressive and fatal. Serum ammonia and INR may also be raised, and ascites often develops during the acute syndrome. The overall pattern of injury resembles acute hepatic necrosis, and liver histology shows centrolobular necrosis and evidence of sinusoidal obstruction. Recovery is rapid and usually complete.

Likelihood score: C (Probable cause of clinically apparent liver injury).

### Mechanism of Injury

Dactinomycin is a direct toxin and likely causes acute damage to hepatic sinusoidal endothelial cells, resulting in sinusoidal obstruction and acute toxic injury to hepatocytes.

### Outcome and Management

The acute hepatic injury caused by dactinomycin is usually self-limiting in course and reversible. Management should focus on supportive care. The mortality rate ranges from 5% to 20%, but most children recover rapidly. Interestingly, the liver injury usually does not recur with retreatment at least with reduced doses of dactinomycin, and long term hepatic consequences are rare.

Drug Class: Antineoplastic Agents

Other Drugs in the Subclass, Antibiotics, Cytotoxic: Bleomycin, Daunorubicin, Doxorubicin, Epirubicin, Idarubicin, Mitomycin, Mitoxantrone, Plicamycin

## CASE REPORT

### Case 1. Acute hepatotoxicity due to dactinomycin therapy.

[Modified from Case 1 in: Farruggia P, Macaluso A, Tropia S, Di Marco F, Russo D, Grigoli A, Trizzino A, D'Angelo P. Hepatopathy-thrombocytopenia syndrome (HTS) after actinomycin-D therapy: report of three cases and review of the literature. Pediatr Hematol Oncol 2011; 28: 237-43. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/21271778)]

An 18 month old girl with Wilms tumor underwent diagnostic and therapeutic resection and was started on dactinomycin [1.5 mg/m^2^] and vincristine [1.5 mg/m^2^]. Nine days after the first course and just after a second dose of vincristine, she developed fever, pallor, marked bruising of the skin, hepatomegaly and ascites. Blood tests showed a hemoglobin of 6.1 g/dL, platelet count 9000/μL, bilirubin 1.1 mg/dL [direct 0.6], ALT 579 U/L, AST 1832 U/L, LDH 5082 U/L and partial thromboplastin time 36 seconds. Serum ammonia levels were normal. Chemotherapy was held and she was monitored (Table). She worsened for several days, but then began to improve and was discharged 15 days later with normal liver tests. Chemotherapy was resumed and she achieved a complete remission and was without evidence of recurrence 12 years later.

#### Key Points

Medication: | Dactinomycin (0.3 mg/m^2^ for 5 days)
Pattern: | Hepatocellular (R value, not available)
Severity: | 4+ (evidence of hepatic and bone marrow failure)
Latency: | 15 days
Recovery: | 15 days
Other medications: | Vincristine

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | AST (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | Normal | Normal | Normal
15 days | 9 days | 579 | 1832 | 1.1 | Platelets 9000/μL
17 days | 11 days | 1000 | 3600 | | LDH 6445 U/L
19 days | 13 days | 346 | 840 | 0.8
30 days | 24 days | Normal | Normal | | Platelets 100,000/μL
Normal Values | | <40 | <40 | <1.2

#### Comment

This distinctive syndrome is commonly referred to as “hepatopathy-thrombocytopenia Syndrome” (HTS) and occurs in 1% to 5% of children who receive cyclic chemotherapy with dactinomycin for treatment of solid tumors such as Wilms tumor and rhabdomyosarcoma. Risk factors appear to be younger age (less than 3 years) and higher doses of dactinomycin. The clinical presentation is striking, with sudden onset of painful hepatomegaly and marked thrombocytopenia with epistaxis, bruising or bleeding. Despite the dire features of the presenting illness, recovery is usually rapid and complete. Strikingly, patients may later tolerate dactinomycin therapy, sometimes in unmodified doses. The cause of HTS is unknown but it resembles acute sinusoidal obstruction syndrome, although the rapidly of recovery is somewhat atypical for this form of hepatic injury. A similar syndrome has been reported in adults treated with dacarbazine (DTIC). An atypical feature of this case was the appearance after the first course of chemotherapy; presentation within a few days of the second or third course being more typical.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Dactinomycin – Generic, Cosmegen®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Dactinomycin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Dactinomycin | 50-76-0 | C62-H86-N12-O16 | Dactinomycin Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 14 November 2017

Zimmerman HJ. Antibiotics. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 694-8. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999 mentions that dactinomycin appears to have little hepatotoxic potential, except when given in high doses or with irradiation which can result in sinusoidal obstruction syndrome).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 541-68. (Review of hepatotoxicity of cancer chemotherapeutic agents mentions that dactinomycin can cause sinusoidal obstruction syndrome, particularly in children with large, right sided Wilms tumor and partial outflow obstruction, which may contribute to the syndrome).
Chabner BA, Bertino J, Cleary J, Ortiz T, Lane A, Supko JG, Ryan DP. Antibiotics. Cytotoxic agents. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1712-5. (Textbook of pharmacology and therapeutics).
Harris F, Cullity G, Lister J. Hepatitis following actinomycin D and irradiation. Proc R Soc Med. 1974; 67: 756-7. (3 year old boy with Wilms tumor treated with dactinomycin and radiotherapy developed sinusoidal obstruction syndrome with edema and ascites 2 month after starting chemotherapy [bilirubin 1.7, ALT 700 U/L, platelets 18,000/μL], ultimately resolving). 4371666
McVeagh P, Ekert H. Hepatotoxicity of chemotherapy following nephrectomy and radiation therapy for right-sided Wilms tumor. J Pediatr 1975; 87: 627-8. (Two 4 year old girls with Wilms tumor developed hepatomegaly, mild AST elevations [45 and 180 U/L] and thrombocytopenia 1-2 months after radiation therapy and starting cycles of dactinomycin and vincristine, resolving completely and later tolerating further dactinomycin therapy). 169340
Jayabose S, Shende A, Lanzkowsky P. Hepatotoxicity of chemotherapy following nephrectomy and radiation therapy for right-sided Wilms tumor. J Pediatr 1976; 88: 898. (Letter in response to McVeagh [1975] with a similar case; 5 year old girl with Wilms tumor developed hepatomegaly 60 days after starting radiation therapy, dactinomycin and vincristine [bilirubin 2.3 mg/dL, ALT 100 U/L], biopsy showing centrilobular congestion and necrosis and liver scan showing a hepatic lesion, all of which ultimately resolved). 178848
Mihevc-Srakar N, Petrić-Grabnar G. [Actinomycin D: toxic effects with special reference to hepatic injury]. Bilt Hematol Transfuz 1979; 7: 85-90. Croatian. (Description of two children treated with dactinomycin who developed hepatotoxicity similar to that described by McVeagh [1975]). 552251
Sznol M, Ohnuma T, Holland JF. Hepatic toxicity of drugs used for hematologic neoplasia. Semin Liver Dis 1987: 237-56. (Review of the hepatotoxicity of cancer chemotherapeutic agents; dactinomycin is not discussed). 3317861
D'Angio GJ. Hepatotoxicity with actinomycin D. Lancet 1987; 2 (8550): 104. (5 of 40 children with Wilms tumor receiving pulsed, intensive regimens of dactinomycin developed "sharp rises in liver function test values", hepatomegaly and ascites; one died and the others recovered fully). 2885556
Green DM, Finklestein JZ, Norkool P, D'Angio GJ. Severe hepatic toxicity after treatment with single-dose dactinomycin and vincristine. A report of the National Wilms' Tumor Study. Cancer 1988; 62: 270-3. (Further description of the 5 children with Wilms tumor who developed liver injury [ascites, hepatomegaly, AST 890 to 19,723 U/L] after 1 to 3 cycles of an intensive dose regimen of dactinomycin). 2838151
Choonara IA, Kendall-Smith S, Bailey CC. Accidental actinomycin D overdosage in man, a case report. Cancer Chemother Pharmacol 1988; 21: 173-4. (17 year old boy with rhabdomyosarcoma received an overdose of dactinomycin [~3.3 instead of 2.5 mg/m^2^] and developed skin rash, peripheral edema, bone marrow suppression, diarrhea, hyponatremia, seizures and mild ALT elevations [rising from 66 to 150 U/L] but ultimately recovered completely). 3349565
Pritchard J, Raine J, Wallendszus K. Hepatotoxicity of actinomycin-D. Lancet 1989; 1 (8630): 168. (Letter in response to D'Angio [1987]; among 279 children with Wilms tumor treated with dactinomycin in the UK, 4 [1.4%] developed severe hepatotoxicity, but 17 [6%] of children overall had severe thrombocytopenia without neutropenia, and some may have had a milder form of the same syndrome). 2563091
D'Angio GJ; De Camargo B. Hepatotoxicity and actinomycin D. Lancet 1990; 335 (8700): 1290. (Two letters; D'Angio from the United States mentions that dactinomycin hepatotoxicity is seen even with the standard doses of dactinomycin used to treat Wilms tumor; De Camargo from Brazil mentions that 4 of 33 children with Wilms tumor treated with the pulsed intensive regimen developed hepatotoxicity, but no case was severe, yet one severe case occurred among the 32 children given the standard dosing regimen). 1971368
Raine J, Bowman A, Wallendszus K, Pritchard J. Hepatopathy-thrombocytopenia syndrome - a complication of dactinomycin therapy for Wilms' tumor: a report from the United Kingdom Childrens Cancer Study Group. J Clin Oncol 1991; 9: 268-73. (Among 501 children with Wilms tumor treated in the UK, 6 developed a syndrome of severe hepatotoxicity with thrombocytopenia [bilirubin 1.3-6.1 mg/dL, ALT 335-5,731 U/L, Alk P 46-412 U/L, platelets 7,000-20,000/μL], all had received dactinomycin; the injury arising within 10 weeks of starting therapy, usually after the 3rd course, resolving in 7-14 days; several children later tolerated lower doses of dactinomycin). 1846405
de Camargo B, Franco EL. A randomized clinical trial of single-dose versus fractionated-dose dactinomycin in the treatment of Wilms' tumor. Results after extended follow-up. Brazilian Wilms' Tumor Study Group. Cancer 1994; 73: 3081-6. (Abstract; 176 Brazilian children with Wilms tumor were randomized to receive dactinomycin in a standard 5 day fractionated course or in a 1 day, pulsed intensive course; response rates were similar and severe hepatotoxicity occurred in only one child who received the fractionated course). 8200006
Arndt C, Hawkins D, Anderson JR, Breitfeld P, Womer R, Meyer W. Age is a risk factor for chemotherapy-induced hepatopathy with vincristine, dactinomycin, and cyclophosphamide. J Clin Oncol 2004; 22: 1894-901. (Among 339 children with rhabdomyo-sarcoma treated with dactinomycin, vincristine and cyclophosphamide, 18 [5%] developed hepatotoxicity [bilirubin 1.4-40 mg/dL, ALT 346-14,046 U/L], usually within 12 weeks of starting, 17 received dactinomycin, 11 with jaundice, 15 with ascites, 4 died; frequency was 15% in children less than 3 years and 4% in older children). 15143082
Mao Y, Wan X, Lv W, Xie X. Relapsed or refractory gestational trophoblastic neoplasia treated with the etoposide and cisplatin/etoposide, methotrexate, and actinomycin D (EP-EMA) regimen. Int J Gynaecol Obstet 2007; 98: 44-7. (Among 18 patients with gestational trophoblastic cancer, hepatotoxicity arose after 17 of 74 cycles [23%] of chemotherapy using etoposide, cisplatin, methotrexate and dactinomycin, but most instances were mild and the timing, clinical features and source of the injury were not provided). 17481633
Takeyama J, Ando R, Sato T, Nio M, Shimanuki Y, Sato A, Imaizumi M. Focal nodular hyperplasia-like lesion of the liver in a child previously treated for nephroblastoma. Pathol Int 2008; 58: 606-8. (6 year old boy was found to have focal nodular hyperplasia 4-5 years after chemotherapy for Wilms tumor with dactinomycin and vincristine, and an episode of sinusoidal obstruction syndrome). 18801077
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, several cases were attributed to antineoplastic agents [such as mercaptopurine, cyclophosphamide, docetaxel, temozolomide, bortezomib and imatinib], but none to dactinomycin). 18955056
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, including 2 attributed to antineoplastic agents, 1 to melphalan and 1 to gemtuzumab, but none to dactinomycin). 20949552
Langholz B, Skolnik JM, Barrett JS, Renbarger J, Seibel NL, Zajicek A, Arndt CA. Dactinomycin and vincristine toxicity in the treatment of childhood cancer: a retrospective study from the Children's Oncology Group. Pediatr Blood Cancer 2011; 57: 252-7. (The rate of all severe toxicities of dactinomycin from 6 clinical trials in 4567 patients was 6% and these adverse events typically occurred early and decreased with cumulative dose). 21671362
Lee AC, Goh PY. Dactinomycin-induced hepatic sinusoidal obstruction syndrome responding to treatment with N-acetylcysteine. J Cancer. 2011; 2: 527-31. (16 year old girl with Wilms tumor developed thrombocytopenia followed by SOS after 5 doses of vincristine and two of dactinomycin [bilirubin 1.1 mg/dL, ALT 746 U/L, ascites], improving rapidly with N-acetylcysteine therapy). 22043237
Farruggia P, Macaluso A, Tropia S, Di Marco F, Russo D, Grigoli A, Trizzino A, D'Angelo P. Hepatopathy-thrombocytopenia syndrome (HTS) after actinomycin-D therapy: report of three cases and review of the literature. Pediatr Hematol Oncol 2011; 28: 237-43. (Three children, ages 15-23 months, with Wilms tumor or rhabdomyosarcoma who received dactinomycin developed severe hepatotoxicity with thrombocytopenia [peak bilirubin 1.0, 3.4, and 2.6 mg/dL, ALT 1000, 851, and 2161 U/L, LDH 6445, 3912 and 10,102 U/L, platelets 9000, 3000 and 11,000/μL], one died while 2 recovered and later tolerated continuation of chemotherapy: Case 1). 21271778
Martín-Lázaro JF, Palanca D, Garcia-Iñiguez JP, Madurga P, Carboné A. Hepatopathy-thrombocytopenia syndrome after actinomycin-D therapy: treatment with defibrotide. Pediatr Hematol Oncol 2013; 30: 25-7. (13 year old female with Wilm tumor developed abdominal pain and fever during a second course of dactinomycin and vincristine [bilirubin 1.7 mg/dL, ALT 1580 U/L, platelet count not given] with worsening coagulopathy and weight gain; was treated with defibrotide [25 mg/kg daily for 14 days] for SOS and recovered rapidly). 23216129
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 were attributed to antineoplastic agents, but none to dactinomycin). 25754159
Baskin Y, Amirfallah A, Calibasi G, Olgun N. Hepatopathy-thrombocytopenia syndrome during actinomycin D treatment may be related to MDR1 (ABCB1) gene polymorphisms. Am J Ther 2016; 23: e594-6. (3.5 year old female with Wilm Tumor developed severe thrombocytopenia during a 4th monthly cycle of dactinomycin and vincristine [bilirubin 0.9 mg/mL, ALT 53 U/L, AST 93 U/L, LDH 332 U/L, platelets 11,000 cells/µL] and was found to have multiple variants of MDR1, but recovered rapidly and later tolerated further cycles of dactinomycin). 24413370
Shi Q, Yang X, Greenhaw JJ, Salminen AT, Russotti GM, Salminen WF. Drug-Induced liver injury in children: clinical observations, animal models, and regulatory status. Int J Toxicol 2017; 36: 365-79. (Review of large series of drug induced liver injury in children lists dactinomycin as causing veno-occlusive disease more commonly in children than adults). 28820004

## OTHER REFERENCE LINKS

1. Recent References on Dactinomycin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Dactinomycin+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Dactinomycin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Dactinomycin)